# Nalmefene

## OVERVIEW

### Introduction

Nalmefene is an opiate receptor antagonist which is used to treat acute opioid overdose and to help in the management of alcohol dependence and addictive behaviors. Nalmefene has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Nalmefene (nal’ me feen) is a semisynthetic opiate receptor antagonist which is similar structurally to naltrexone and oxymorphone. Nalmefene is distinctive in having antagonist activity against all three types of opiate receptors – μ, κ and δ. When given intravenously or intramuscularly, nalmefene causes rapid onset of withdrawal symptoms in opioid dependent persons and has been used successfully to treat acute opioid overdose. It is also used to reverse opioid actions in the postoperative period. It has a longer duration of action than naloxone and better oral availability. Nalmefene was approved for use in the United States in 1995 as a therapy of opioid overdose. Oral formulations, which have been used to treat alcohol dependence and other addictive behaviors, have not been approved for this use in the United States. Nalmefene is available in solutions for injection in concentrations of 100 μg/mL (for postoperative use) and 1 mg/mL (for management of known of suspected opioid overdose) under the trade name Revex. Side effects of parenterally administered nalmefene in opioid dependent patients include mood changes, sweating, anxiety, restlessness, trembling, dizziness, flushing, headache, nausea, vomiting, cardiac tachyarrhythmias, seizures, chest pain and acute pulmonary edema—symptoms of acute opioid withdrawal. In persons not taking opioids, nalmefene has minimal effects. Nalmefene is not a controlled substance, but its use is sometimes restricted to medical staff trained in emergency medicine or anesthesia.

### Hepatotoxicity

Therapy with nalmefene has not been linked to serum enzyme elevations or to idiosyncratic acute, clinically apparent liver injury. Nalmefene is extensively metabolized in the liver, but largely by glucuronidation rather than transformation to a different metabolite. Patients with opioid overdose often have underlying chronic liver diseases such as alcoholic liver disease, hepatitis B or C, but treatment with nalmefene does not appear to exacerbate those conditions.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Opioid Antagonists; see also Substance Abuse Treatment Agents

Other Drugs in the Class: Naloxegol, Naloxone, Naltrexone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nalmefene – Revex®

DRUG CLASS

Opioid Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=49fd02f8-12b8-460c-ae1f-f26738d86998)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Nalmefene HCl | 58895-64-0 | C21-H25-N-O3.Cl-H

## ANNOTATED BIBLIOGRAPHY

References updated: 24 March 2020

Zimmerman HJ. Narcotic analgesics. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 710-11. (Expert review of hepatotoxicity published in 1999; mentions that trials of naltrexone have reported serum aminotransferase elevations in up to 30% of recipients, an effect that appeared to be partially dose dependent; nalmefene not discussed).
Larrey D, Ripault MP. Illegal and recreational compounds. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 456-7. (Review of hepatotoxicity discusses buprenorphine, an orally available morphine analogue, which has been linked to cases of severe acute liver injury, usually as a result of intravenous administration; nalmefene not discussed).
Yaksh TL, Wallace MS. Opioids, analgesia, and pain management. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 355-86. (Textbook of pharmacology and therapeutics).
Dixon R, Gentile J, Hsu HB, Hsiao J, Howes J, Garg D, Weidler D. (1987). Nalmefene: safety and kinetics after single and multiple oral doses of a new opioid antagonist. J Clin Pharmacol. (Phase 1 study of safety of single injections and 7 day courses of nalmefene in different doses found no increases in serum aminotransferase levels).
Kaplan JL, Marx JA. (1993). Effectiveness and safety of intravenous nalmefene for emergency department patients with suspected narcotic overdose: a pilot study. Ann Emerg Med. (Among 53 patients with suspected opioid overdose who were treated with 1-10 boluses of either 0.5 and 1.0 mg of intravenous nalmefene, no serious adverse events were found; side effects possibly related to nalmefene were vomiting, dizziness and diarrhea).
Mason BJ, Ritvo EC, Morgan RO, Salvato FR, Goldberg G, Welch B, Mantero-Atienza E. (1994). A double-blind, placebo-controlled pilot study to evaluate the efficacy and safety of oral nalmefene HCl for alcohol dependence. Alcohol Clin Exp Res. (Controlled trial of 12 weeks of nalmefene or placebo in 21 alcohol dependent patients found no difference in laboratory measures during therapy, serum ALT levels decreasing in abstinent patients).
Bergasa NV, Schmitt JM, Talbot TL, Alling DW, Swain MG, Turner ML, Jenkins JB, et al. (1998). Open-label trial of oral nalmefene therapy for the pruritus of cholestasis. Hepatology. (Open label trial of nalmefene for 2-26 months in 14 patients with liver disease and pruritus found "no consistent effect of nalmefene on the severity of cholestasis, as assessed by routine serum biochemical markers").
Kaplan JL, Marx JA, Calabro JJ, Gin-Shaw SL, Spiller JD, Spivey WL, Gaddis GM, Zhao N, Harchelroad FP. (1999). Double-blind, randomized study of nalmefene and naloxone in emergency department patients with suspected narcotic overdose. Ann Emerg Med. (Controlled trial of two doses of nalmefene vs naloxone in 118 patients with suspected opioid overdose found similar rates of response and adverse events; the most common ones attributed to nalmefene were vomiting, tachycardia, nausea and myoclonus).
Anton RF, Pettinati H, Zweben A, Kranzler HR, Johnson B, Bohn MJ, McCaul ME, et al. (2004). A multi-site dose ranging study of nalmefene in the treatment of alcohol dependence. J Clin Psychopharmacol. (Among 270 recently abstinent alcohol dependent subjects treated with one of 3 doses of nalmefene or placebo for 12 weeks, side effects of nausea, dry mouth, insomnia, dizziness and confusion were more common in nalmefene treated patients; no mention of ALT and AST results).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to nalmefene, naltrexone or other agents used to treated substance abuse).
van den Brink W, Aubin HJ, Bladström A, Torup L, Gual A, Mann K. (2013). Efficacy of as-needed nalmefene in alcohol-dependent patients with at least a high drinking risk level: results from a subgroup analysis of two randomized controlled 6-month studies. Alcohol Alcohol. (Retrospective analysis of 667 alcohol dependent patients treated with nalmefene or placebo on an as-needed basis for 6 months found decrease in average GGT and ALT values during the study, with greater decrease in nalmefene treated subjects).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to nalmefene or other opioid antagonists).
van den Brink W, Sørensen P, Torup L, Mann K, Gual A, SENSE Study Group. (2014). Long-term efficacy, tolerability and safety of nalmefene as-needed in patients with alcohol dependence: A 1-year, randomised controlled study. J Psychopharmacol. (Among 675 alcohol dependent patients treated with nalmefene (18 mg) or placebo once daily for 1 year, decreases in alcohol intake were greater with nalmefene at 1 year (but not 6 months), and there were no differences in the incidence of clinically relevant laboratory values between the 2 treatment groups” except in ALT and AST values, but specific differences were not described).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to nalmefene or other opioid antagonists).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to nalmefene or other opioid antagonists).
van den Brink W, Strang J, Gual A, Sørensen P, Jensen TJ, Mann K. (2015). Safety and tolerability of as-needed nalmefene in the treatment of alcohol dependence: results from the Phase III clinical programme. Expert Opin Drug Saf. (Among 1123 patients treated with “as needed” nalmefene and 824 with placebo for alcohol dependency in 3 controlled trials, adverse events more frequent with nalmefene included nausea [22 vs 6%], dizziness [18% vs 6%, insomnia [13% vs 5%] and headache [12% vs 8%], but not ALT or AST elevations above 3 times ULN [3.8% vs 3.9%] and there were no episodes of clinically apparent liver injury).
Johansen KGV, Tarp S, Astrup A, Lund H, Pagsberg AK, Christensen R. (2017). Harms associated with taking nalmefene for substance use and impulse control disorders: A systematic review and meta-analysis of randomised controlled trials. PLoS One. (Metaanalysis of 8 controlled trials found similar rates of serious adverse events and deaths in nalmefene vs placebo recipients but higher rates of discontinuation because of adverse events; no mention of ALT elevations or hepatotoxicity).
Castera P, Stewart E, Großkopf J, Brotons C, Brix Schou M, Zhang D, Steiniger Brach B, et al., PICASO Study Investigators. (2018). Nalmefene, given as needed, in the routine treatment of patients with alcohol dependence: an interventional, open-label study in primary care. Eur Addict Res. (Among 378 patients with alcohol dependency treated with open-label “as-needed” nalmefene, side effects included nausea (18%) and dizziness (18%), and one patient died of decompensated cirrhosis that was considered unrelated to the therapy and there were no other “clinically relevant changes” in laboratory values).
Chaignot C, Zureik M, Rey G, Dray-Spira R, Coste J, Weill A. (2018). Risk of hospitalisation and death related to baclofen for alcohol use disorders: Comparison with nalmefene, acamprosate, and naltrexone in a cohort study of 165 334 patients between 2009 and 2015 in France. Pharmacoepidemiol Drug Saf. (Analysis of the French Health Insurance claims database of patients initiating alcohol use disorder therapies found an increased risk of hospitalization [+13%] and death [+31%] compared to exposure to approved drugs such as acamprosate, naltrexone and nalmefene).
(2018). Opioids for pain. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of opioids used for pain mentions that the 3 opioid antagonists that are used to treat opioid induced constipation-methylnaltrexone, naloxegol and nalmedine-have similar degrees of efficacy and toxicities).
Miyata H, Takahashi M, Murai Y, Tsuneyoshi K, Hayashi T, Meulien D, Sørensen P, et al. (2019). Nalmefene in alcohol-dependent patients with a high drinking risk: Randomized controlled trial. Psychiatry Clin Neurosci. (Among 594 Japanese patients with alcohol dependency treated with as-needed nalmefene or placebo for 12 weeks, alcohol use was less with nalmefene treatment while adverse events were more frequent; although “there were no clinically significant laboratory findings”, one patient discontinued nalmefene therapy because of chronic hepatitis).
López-Pelayo H, Zuluaga P, Caballeria E, Van den Brink W, Mann K, Gual A. (2020). Safety of nalmefene for the treatment of alcohol use disorder: an update. Expert Opin Drug Saf. (Review of the safety of nalmefene as therapy of alcohol use disorders mentions that while “there is no evidence of hepatotoxicity associated with nalmefene, there is a lack of data involving patients with advanced liver disease”).

## OTHER REFERENCE LINKS

1 Recent References on Nalmefene: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Nalmefene+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nalmefene: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nalmefene)